# Busulfan

## OVERVIEW

### Introduction

Busulfan is an orally administered anticancer alkylating agent used in the treatment of chronic myelogenous leukemia, as well as a parenterally administered myeloablative agent used in preparation of hematopoietic cell transplantation (HCT). Busulfan has been linked to transient serum enzyme elevations during therapy, to rare cases of cholestatic hepatitis, instances of nodular regenerative hyperplasia and, when given in high doses, to sinusoidal obstruction syndrome which can be severe and fatal.

### Background

Busulfan (bue sul' fan) is an alkylating agent of the alkylsulfonate type containing several methanesulfonate groups, which are hydrolyzed in aqueous solution and released to form reactive carbonium ions that alkylate DNA causing inhibition of DNA, RNA and protein synthesis and triggering cell death in rapidly dividing cells. Busulfan is effective in the palliative treatment of chronic myelogenous leukemia and as part of a myeloablative regimen in preparation of bone marrow or stem cell transplantation. Busulfan was approved for clinical use in the United States in 1954 and is still in wide use. Busulfan is available in tablets of 2 mg under the brand name of Myleran and in solution for intravenous infusion (6 mg/mL) as Busulflex. The recommended dosage is dependent on the disease process and patient age, body weight and comorbidities. Common side effects of busulfan include fatigue, weakness, dizziness, oral ulcers, pharyngitis, nausea, anorexia, abdominal discomfort and bone marrow suppression.

### Hepatotoxicity

Oral busulfan therapy is associated with a low rate of serum enzyme elevations that are typically transient, mild and usually do not require dose adjustment. Rare instances of clinically apparent acute liver disease have been described in patients taking oral busulfan long term. The onset of injury is usually after years of therapy, and the pattern of serum enzyme elevations is usually cholestatic (Case 1). At least one case of cholestatic injury was reported to lead to hepatic failure.

Perhaps complicating the issue of interpretation of liver enzyme elevations during busulfan therapy is that chronic use of busulfan has been linked to cases of nodular regenerative hyperplasia. This process also arises at least six months if not years of therapy with busulfan or antimetabolites (azathioprine, thioguanine) and typically presents with signs of portal hypertension (varices, variceal hemorrhage, ascites) and minimal, nonspecific symptoms and serum enzyme elevations. Thrombocytopenia is almost always present and is often the first sign of evolving portal hypertension. Nodular regeneration usually starts to improve within a few weeks to months of stopping the antineoplastic or immunosuppressive therapy. However, in some cases the complications of portal hypertension are severe and can result in hepatic failure particularly if complicated by septicemia or other organ failure (Case 2).

Finally, and most importantly, busulfan given in high doses intravenously combined with total body irradiation, cyclophosphamide, or other alkylating agents in preparation for either bone marrow or stem cell transplantation (hematopoietic cell transplantation, HCT) has been linked to sinusoidal obstruction syndrome (SOS, formerly referred to as veno-occlusive disease). The onset of injury is usually within 10 to 20 days of HCT and presents with abdominal pain, liver tenderness, weight gain due to fluid accumulation, and jaundice. With some newer conditioning regimens, sinusoidal obstruction syndrome can present later, 30 to 75 days after HCT. The serum enzymes are usually elevated, typically with marked increases in serum aminotransferase levels (and lactic dehydrogenase), but minimal increases in alkaline phosphatase. In severe cases, there is hepatomegaly and ascites and signs of hepatic failure arise. Sinusoidal obstruction syndrome tends to be severe and the fatality rate can be as high as 50%. Poor prognostic signs are marked increases in serum ALT levels and high bilirubin levels. In fatal instances, death from multiorgan failure arises within days to weeks of onset. In cases with spontaneous recovery, there may be residual fibrosis or nodular regeneration. Autoantibody formation and allergic manifestations are uncommon, although fever may be present at onset. Risk factors for the development of sinusoidal obstruction syndrome are higher doses of busulfan, combination with cyclophosphamide and total body irradiation, pharmacokinetics that favor higher busulfan or cyclophosphamide exposure, and preexisting liver disease, particularly chronic hepatitis C. The frequency of sinusoidal obstruction syndrome after HCT ranges from 20% to 50%, but its incidence has decreased markedly in recent years with use of less aggressive conditioning regimens, better control over drug dosing, and lower frequency of hepatitis C (with elimination of posttransfusion hepatitis after anti-HCV testing of all blood donors).

Likelihood score: A (well known cause of clinically apparent liver injury, generally as a result of direct toxicity from high doses given for myeloablation in preparation for hematopoietic cell transplantation and rarely due to idiosyncratic liver injury).

### Mechanism of Injury

Although the mechanism of idiosyncratic hepatotoxicity from busulfan is not clear, the drug undergoes extensive hepatic metabolism. Nodular regeneration is thought to be due to damage of small vasculature in the liver. Sinusoidal obstruction syndrome appears to be the result of direct cytotoxicity of busulfan and other agents to the hepatic sinusoidal lining cells, causing their extrusion and obstruction of sinusoids, congestion and centrolobular hepatic necrosis.

### Outcome and Management

In cases of idiosyncratic liver injury, symptoms and liver enzymes abnormalities resolve within 1 to 2 months of stopping busulfan. Sinusoidal obstruction syndrome tends to be severe and the fatality rate is high. In patients who recover from sinusoidal obstruction syndrome, residual fibrosis and nodular regeneration may be present. Rechallenge with busulfan after clinically apparent liver injury should be avoided.

Drug Class: Antineoplastic Agents, Alkylating Agents

## CASE REPORTS

### Case 1. Cholestatic liver disease attributed to long term busulfan therapy.

[Modified from: Morris LE, Guthrie TH Jr. Busulfan-induced hepatitis. Am J Gastroenterol 1988; 83: 682-3. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/3376924)]

A 61 year old man with chronic myelocytic leukemia developed fatigue, abdominal pain and fever after having been on busulfan in varying doses for 8 years. He had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. His only other medication was hydrochlorothiazide which he took for hypertension. On examination, he was febrile (38.5 ^o^C), but had no jaundice, rash or hepatomegaly. Laboratory tests showed serum bilirubin of 0.9 mg/dL, ALT 77 U/L, AST 47 U/L, GGT 682 U/L, and alkaline phosphatase 449 U/L. Abdominal ultrasound showed no evidence of gallstones or biliary obstruction. Tests for hepatitis A and B were negative. A liver biopsy showed intrahepatic cholestasis and mild hepatocellular necrosis with minimal inflammation. His abdominal pain resolved rapidly but he continued to have low grade fevers. The pattern of liver enzyme elevations did not change and serum bilirubin remained normal. Two weeks after admission, busulfan and hydrochlorthiazide were discontinued and the fevers rapidly abated. In follow up two weeks later, he was asymptomatic and liver enzymes had decreased. One year later serum enzymes were normal. He had been switched to another thiazide diuretic.

#### Key Points

Medication: | Busulfan
Pattern: | Cholestatic (R=~0.5)
Severity: | 1+ (serum enzyme elevations and symptoms without jaundice)
Latency: | 8 years
Recovery: | 2 weeks
Other medications: | Hydrochlorothiazide

#### Comment

This patient developed a drug-fever accompanied by cholestatic serum enzyme elevations after 8 years of variable doses of busulfan. Such a long latency to onset is unusual for drug induced liver injury, but the patient had probably stopped and started the medication multiple times and was taking busulfan three times weekly at the time of onset of symptoms. The most convincing evidence for the role of busulfan was the persistence of fever while the medication was continued and its prompt resolution when busulfan was stopped. The only complicating issue is that hydrochlorthiazide was also being taken and was stopped at the same time.

### Case 2. Nodular regenerative hyperplasia due to chronic therapy with busulfan and thioguanine.

[Modified from Case B in: Key NS, Kelly PM, Emerson PM, Chapman RW, Allan NC, McGee JO. Oesophageal varices associated with busulphan-thioguanine combination therapy for chronic myeloid leukaemia. Lancet 1987; 2: 1050-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/2889964)]

A 58 year old woman with chronic myelogenous leukemia was treated with the combination of busulfan and thioguanine with an excellent palliative response. However, 16 months after starting combination therapy, she had acute upper gastrointestinal hemorrhage due to previously unsuspected esophageal varices. She had no history of liver disease, alcohol abuse or risk factors for viral hepatitis. Physical examination revealed splenomegaly and ascites. Serum bilirubin was 2.2 mg/dL, AST 65 U/L, Alk P 398 U/L, and INR was elevated at 1.5. Abdominal ultrasound showed a coarse liver texture, splenomegaly and ascites, but patent hepatic and portal veins. She continued to have variceal hemorrhage and underwent esophageal transection under general anesthesia. Postoperatively, she developed pneumonia, and progressive hepatic and respiratory failure and died. Autopsy showed a large liver (2110 grams) with a nodular surface. The hepatic veins were patent, but the portal vein contained a recent thrombus. Histologically, the liver showed diffuse regenerative hyperplasia with minimal fibrosis. There was sinusoidal infiltration by leukemic cells.

#### Key Points

Medication: | Busulfan and thioguanine
Pattern: | Cholestatic (R=0.7)
Severity: | 5+ (hepatic failure and death)
Latency: | 16 months
Recovery: | None
Other medications: | None

#### Comment

Chronic busulfan therapy, particularly when combined with thioguanine, has been linked to cases of noncirrhotic portal hypertension due to nodular regeneration hyperplasia. The process is often silent and serum enzymes are minimally and nonspecifically elevated. The first sign of impending portal hypertension is usually a fall in platelet count, but such changes are often attributed to the underlying condition or to bone marrow suppression by the alkylating agent or antimetabolite. The cause of nodular regeneration is unknown, but it is likely due to injury to the hepatic vasculature, and close inspection of portal areas in liver tissue usually shows injury or paucity of small portal veins. While the nodular regeneration leads to portal hypertension, hepatic function is usually preserved until there is a severe complication such as bleeding, hemodynamic instability and septicemia, at which time jaundice and other signs of hepatic failure can arise. This complication has led to the avoidance of the combination of thioguanine and busulfan as palliative therapy for chronic leukemia.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Busulfan – Myleran®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Busulfan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Busulfan | 55-98-1 | C6-H14-O6-S2 | Busulfan Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 October 2017

Zimmerman HJ. Alkylating Agents. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 678-80. (Expert review of alkylating agents published in 1999; mentions that busulfan had been implicated in cholestatic jaundice, nodular regenerative hyperplasia [with thioguanine] and sinusoidal obstruction syndrome [SOS]).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 551. (Review of hepatotoxicity of cancer chemotherapeutic agents mentions that busulfan has been linked to rare cases of cholestatic hepatitis, nodular regeneration [NRH] and sinusoidal obstruction syndrome [SOS]).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics; busulfan is an alkyl sulfonate, its major adverse effect is myelosuppression; high doses cause SOS in up to 10% of patients).
Kyle RA, Dameshek W. Porphyria cutanea tarda associated with chronic granulocytic leukemia treated with busulfan (Myleran). Blood 1964; 23: 776-85. (55 year old man with chronic myelogenous leukemia developed blast crisis, hyperpigmentation and elevations in urinary porphyrins while on busulfan therapy, liver tests were normal; autopsy showed iron overload). 14161411
Underwood JC, Shahani RT, Blackburn EK. Cholestatic jaundice following treatment of chronic granulocytic leukemia with busulphan. J Clin Pathol 1970; 23: 827. (25 year old man with chronic granulocytic leukemia developed jaundice after 6 years of maintenance busulfan [bilirubin 2.3 mg/dL, ALT 32 U/L, Alk P 3 times ULN], with progressive hepatic failure and death one month later). 5278972
Shulman HM, McDonald GB, Matthews D, Doney KC, Kopecky KJ, Gauvreau JM, Thomas ED. An analysis of hepatic venocclusive disease and centrilobular hepatic degeneration following bone marrow transplantation. Gastroenterology 1980; 79: 1178-91. (Analysis of liver biopsies from 204 patients who had undergone HCT for various malignancies, finding SOS in 27 patients, early lesions being centrilobular congestion, hepatocyte degeneration and subintimal edema within small central venules and later lesions fibrous obliteration of central venule lumina and fibrosis; correlated with more aggressive conditioning regimens including those with busulfan). 7002704
Farthing MJG, Clark MI, Sloan JP, Powles RI, McElwain TJ. Liver disease after bone marrow transplantation. Gut 1982; 23: 465-74. (Among 43 patients with HCT, 83% had elevations in liver tests and 7 died of liver disease; diagnoses being graft-vs-host disease in 48%, SOS in 5% [2 fatal cases] and multifactorial liver injury). 7042484
Santos GW, Tutschka PJ, Brookmeyer R, Saral R, Beschorner WE, Bias WB, Braine HG, et al. Marrow transplantation for acute nonlymphocytic leukemia after treatment with busulfan and cyclophosphamide. N Engl J Med 1983; 309: 1347-53. (Pilot study of HCT for nonlymphocytic leukemia using a conditioning regimen of cyclophosphamide and busulfan; SOS occurred in only 3 patients which was considered lower than occurs with busulfan alone or with total body irradiation combined with cyclophosphamide). 6355849
McDonald GB, Sharma P, Matthews DE, Shulman HM, Thomas ED. Venocclusive disease of the liver after bone marrow transplantation: diagnosis, incidence, and predisposing factors. Hepatology 1984; 4: 116-22. (Among 255 patients undergoing HCT, 53 [21%] met criteria for SOS, its occurrence associated with older age, underlying liver disease, AST levels and diagnosis). 6363247
McDonald GB, Sharma P, Matthews DE, Shulman HM, Thomas ED. The clinical course of 53 patients with venocclusive disease of the liver after marrow transplantation. Transplantation 1985; 39: 603-8. (Among 255 patients undergoing HCT for malignant disease, 53 [21%] developed SOS, marked by weight gain [93%] starting ~6 days after transplant followed by jaundice [98%: bilirubin 3.6-29.4 mg/dL], abdominal pain [75%], liver enlargement [68%]; 24 [45%] had serious progressive disease with ascites and hepatic encephalopathy and 17 [32%] died). 3890288
Hartmann O, Benhamou E, Beaujean F, Pico JL, Kalifa C, Patte C, Flamant F, et al. High-dose busulfan and cyclophosphamide with autologous bone marrow transplantation support in advanced malignancies in children: a phase II study. J Clin Oncol 1986; 4: 1804-10. (Results of using busulfan and cyclophosphamide for HCT in 20 children: AST elevations occurred in 6 but severe SOS in only one child). 3537217
Key NS, Kelly PM, Emerson PM, Chapman RW, Allan NC, McGee JO. Oesophageal varices associated with busulphan-thioguanine combination therapy for chronic myeloid leukaemia. Lancet 1987; 2: 1050-2. (Case series of 5 patients who developed abnormal liver tests 6 to 45 months after starting busulfan and thioguanine for chronic myelocytic leukemia with varices found after 16 to 98 months, biopsies showing nodular regeneration: Case 2). 2889964
Peters WP, Henner WD, Grochow LB, Olsen G, Edwards S, Stanbuck H, Stuart A, et al. Clinical and pharmacologic effects of high dose single agent busulfan with autologous bone marrow support in the treatment of solid tumors. Cancer Res 1987; 47: 6402-6. (6 patients with advanced cancer received 4 days of high dose busulfan [16 mg/kg]; had limited efficacy and all developed bilirubin elevations and 2 had transient immunological syndromes: lupus and chronic active hepatitis, but these syndromes resolved without residal evidence of liver injury). 2824032
Jones RJ, Lee KS, Beschorner WE, Vogel VG, Grochow LB, Braine HG, Vogelsang GB, et al. Veno-occlusive disease of the liver following bone marrow transplantation. Transplantation 1987; 4: 778-83. (Among 235 patients undergoing HCT between 1982 and 1985, sinusoidal obstruction syndrome [SOS] developed in 52 [22%] of whom half died, making SOS the third most common cause of death in this population). 3321587
Morris LE, Guthrie TH Jr. Busulfan-induced hepatitis. Am J Gastroenterol 1988; 83: 682-3. (61 year old man with chronic myelocytic leukemia developed fever and alkaline phosphatase elevations after 8 years of busulfan therapy [bilirubin 0.9 mg/dL, ALT 77 U/L, Alk P 449 U/L], which resolved only once busulfan was stopped: Case 1). 3376924
Brugieres L, Hartmann O, Benhamou E, Patte C, Kalifa C, Lemerle J. [Hepatic complications after high-dose chemotherapy and bone marrow autograft in solid tumors in children]. Presse Med 1988; 17: 1305-8. French. (Among 236 children receiving HCT between 1979 and 1987, liver disease arose after 43 courses [20%] in 39 patients, including SOS in 11 [5%] which was fatal in 4; risk factors included use of busulfan and previous high dose chemotherapy). 2969580
Brugieres L, Hartmann O, Benhamou E, Zafrani ES, Caillaud JM, Patte C, Kalifa C, et al. Veno-occlusive disease of the liver following high-dose chemotherapy and autologous bone marrow transplantation in children with solid tumors: incidence, clinical course and outcome. Bone Marrow Transplant 1988; 3: 53-8. (Among 173 children undergoing 236 courses of high dose chemotherapy and HCT, 39 children had hepatic abnormalities and 11 met the criteria for having SOS; syndrome marked by weight gain [decrease in sodium excretion] with weight gain of 5-12% followed by hepatomegaly and jaundice [bilirubin 4.5-26.9 mg/dL, ALT 60-1850 U/L, Alk P 1.5-2.5 times ULN]; 4 patients [2%] died). 3048471
Grochow LB, Jones RJ, Brundrett RB, Braine HG, Chen T-L, Saral R, Santos GW, et al. Pharmacokinetics of busulfan: correlation with veno-occlusive disease in patients undergoing bone marrow transplantation. Cancer Chemother Pharmacol 1989; 25: 55-61. (Analysis of busulfan pharmacokinetics in 15 patients undergoing HCT after conditioning with busulfan and cyclophosphamide showed marked variability in disposition and higher area under the curve plasma levels in 6 patients developing SOS). 2591002
Adang RP, Breed WP. [Liver damage during busulfan therapy]. Ned Tijdschr Geneeskd 1989; 133: 1515-8. Dutch. (57 year old man with chronic megakaryocytic granulocytic myelosis, who was treated with intermittent low dose busulfan for 2 years, developed fatigue and elevations in liver enzymes [peak ALT 27 U/L, Alk P 602 U/L, bilirubin normal], improving but not resolving completely upon stopping busulfan). 2797253
Peters WG. [Liver damage during busulfan therapy]. Reply by authors. Ned Tijdschr Geneeskd 1989; 133:1849-50. Dutch. (Letter in response to Adang [1989] suggesting that the cause of the abnormalities was SOS [although nodular regeneration was more likely]). 2797298
Snover DC, Weisdorf S, Bloomer J, McGlave P, Weisdorf D. Nodular regenerative hyperplasia of the liver following bone marrow transplantation. Hepatology 1989; 9: 443-8. (Retrospective review of liver histology from 101 patients after HCT found SOS in 9% vs nodular regeneration in 23%, which were often indistinguishable clinically). 2646196
Vassal G, Hartmann O, Benhamou E. Busulfan and veno-occlusive disease of the liver. Ann Intern Med 1990; 112: 881. (Among 403 children receiving busulfan for HCT, 28 [7%] developed SOS and 3 died; occurrence associated with higher doses). 2344115
Shepherd P, Harrison DJ. Idiopathic portal hypertension associated with cytotoxic drugs. J Clin Pathol 1990; 43: 206-10. (4 cases of portal hypertension developing in patients on thioguanine and busulfan for leukemia or chlorambucil for Hodgkin disease after 21-70 months, often with variable elevations in alkaline phosphatase). 2332518
Shepherd PC, Fooks J, Gray R, Allan NC. Thioguanine used in maintenance therapy of chronic myeloid leukaemia causes non-cirrhotic portal hypertension. Results from MRC CML. II. Trial comparing busulphan with busulphan and thioguanine. Br J Haematol 1991; 79: 185-92. (Among 674 patients with chronic leukemia, 18 of 337 [5%] treated with busulfan and thioguanine developed portal hypertension after 1 to 8 years [median 2 years], compared to none of 338 given busulfan alone, whereas liver test abnormalities [~50%] and jaundice [~3%] occurred in similar proportions of both groups). 1958475
Morgan M, Dodds A, Atkinson K, Szer J, Downs K, Biggs J. The toxicity of busulphan and cyclophosphamide as the preparative regimen for bone marrow transplantation. Br J Haematol 1991; 77: 529-34. (Retrospective analysis found SOS occurring in 12 of 67 patients [19%: one fatality] receiving busulfan and irradiation in preparation of HCT, compared to only 2 of 166 [1.3%] receiving cyclophosphamide and irradiation). 2025579
Ozkaynak MF, Weinberg K, Kohn D, Sender L, Parkman R, Lenarsky C. Hepatic veno-occlusive disease post-bone marrow transplantation in children conditioned with busulfan and cyclophosphamide: incidence, risk factors, and clinical outcome. Bone Marrow Transplant 1991; 7: 467-74. (Retrospective analysis found SOS in 14 of 50 [36%] children given busulfan and cyclophosphamide in preparation for HCT, the injury arising 13-30 days after transplant and ultimately resolving in all). 1908340
Kasai M, Kiyama Y, Watanabe M, Seto K, Matsuura A, Tanaka J, Takeda H, et al. Toxicity of high-dose busulfan and cyclophosphamide as a preparative regimen for bone marrow transplantation. Transplant Proc 1992; 24: 1529-30. (Among 16 patients given a regimen which included busulfan and cyclophosphamide in preparation of HCT, 4 developed SOS and died within 1-2 months). 1496647
Méresse V, Hartmann O, Vassal G, Benhamou E, Valteau-Couanet D, Brugieres L, Lemerle J. Risk factors for hepatic veno-occlusive disease after high-dose busulfan-containing regimens followed by autologous bone marrow transplantation: a study in 136 children. Bone Marrow Transplant 1992; 10: 135-41. (Among 136 children undergoing autologous HCT after conditioning with busulfan [with or without melphalan, thiotepa, or cyclophosphamide], 30 [22%] developed SOS by clinical criteria and 4 died [3%]; predictive risk factors included dose of alkylating agents in conditioning regimen). 1525602
McDonald GB, Hinds MS, Fisher LD, Schoch HG, Wolford JL, Banaji M, Hardin BJ, et al. Veno-occlusive disease of the liver and multiorgan failure after bone marrow transplantation: a cohort study of 355 patients. Ann Intern Med 1993; 118: 255-67. (Prospective analysis of 355 patients undergoing HCT; SOS developed in 54% and was severe in 16%, higher rates were associated with the combination of busulfan with cyclophosphamide [32%] and with total body irradiation [23%]; mortality rate being 98% in those with severe injury). 8420443
Rosenthal MA, Grigg AP, Sheridan WP. High dose busulphan/cyclophosphamide for autologous bone marrow transplantation is associated with minimal non-hemopoietic toxicity. Leuk Lymphoma 1994; 14: 279-83. (Among 69 patients receiving busulfan and cyclophosphamide in preparation of HCT, 16 [23%] developed liver toxicity but most cases were mild; 6 patients developed SOS [9%] but only one died). 7524888
Bearman SI. The syndrome of hepatic veno-occlusive disease after marrow transplantation. Blood 1995; 85: 3005-20. (Review of hepatic SOS after HCT; usually presents with painful hepatomegaly, weight gain [fluid and ascites] and jaundice within 3 weeks of myeloablation, histology showing occlusion of small central veins and sinusoids and extensive zone 3 [centrolobular] injury). 7756636
Dix SP, Wingard JR, Mullins RE, Jerkunica I, Davidson TG, Gilmore CE, York RC, et al. Association of busulfan area under the curve with veno-occlusive disease following BMT. Bone Marrow Transplant 1996; 17: 225-30. (Pharmacokinetic study of busulfan during myeloablative preparation of patients for HCT found higher rate of SOS with the combination of cyclophosphamide and busulfan [4 of 10: 40%] compared to busulfan with etoposide [7 of 38] or Ara-C [1 of 18], despite similar drug levels). 8640171
Styler MJ, Crilley P, Biggs J, Moul J, Copelan E, Topolsky D, Avalos B, et al. Hepatic dysfunction following busulfan and cyclophosphamide myeloablation: a retrospective, multicenter analysis. Bone Marrow Transplant 1996; 18: 171-6. (Among 350 patients treated with busulfan and cyclophosphamide in preparation of HCT, 27% developed SOS, 11% being severe). 8832011
Atra A, Whelan JS, Calvagna V, Shankar AG, Ashley S, Shepherd V, Souhami RL, et al. High-dose busulphan/melphalan with autologous stem cell rescue in Ewing's sarcoma. Bone Marrow Transplant 1997; 20: 843-6. (Among 18 patients given busulfan and melphalan in preparation for HCT, only one patient developed SOS, which was not fatal). 9404924
Diaz MA, Vicent MG, Madero L. High-dose busulfan/melphalan as conditioning for autologous PBPC transplantation in pediatric patients with solid tumors. Bone Marrow Transplant 1999; 24: 1157-9. (Among 30 children given busulfan and melphalan in preparation for HCT, 3 developed transient liver test abnormalities and one developed fatal SOS). 10642802
Lee JL, Gooley T, Bensinger W, Schiffman K, McDonald GB. Veno-occlusive disease of the liver after busulfan, melphalan, and thiotepa conditioning therapy: incidence, risk factors, and outcome. Biol Blood Marrow Transplant 1999; 5: 306-15. (Among 253 patients who received a regimen of busulfan, melphalan and thiotepa in preparation for HCT, 70 [28%] developed SOS, which was severe in 11 and fatal in 9). 10534061
Hassan M, Ljungman P, Ringden O, Hassan Z, Oberg G, Nilsson C, Bekassy A, et al. The effect of busulphan on the pharmacokinetics of cyclophosphamide and its 4-hydroxy metabolite: time interval influence on therapeutic efficacy and therapy-related toxicity. Bone Marrow Transplant 2000; 25: 915-24. (Cyclophosphamide given sooner rather than later after busulfan in preparation for HCT was associated with a higher rate of side effects including SOS [58% vs 14%]). 10800057
Olavarria E, Hassan M, Eades A, Nilsson C, Timms A, Matthews J, Craddock C, et al. A phase I/II study of multiple-dose intravenous busulfan as myeloablation prior to stem cell transplantation. Leukemia 2000; 14: 1954-9. (In a pilot study of an intravenous preparation of busulfan, none of 12 patients undergoing HCT developed SOS). 11069031
Kashyap A, Wingard J, Cagnoni P, Roy J, Tarantolo S, Hu W, Blume K, et al. Intravenous versus oral busulfan as part of a busulfan/cyclophosphamide preparative regimen for allogeneic hematopoietic stem cell transplantation: decreased incidence of hepatic venoocclusive disease (HVOD), HVOD-related mortality, and overall 100-day mortality. Biol Blood Marrow Transplant 2002; 8: 493-500. (Retrospective analysis found a higher rate of SOS after oral [33%: 10 of 30] vs intravenous [8%: 5 of 61] busulfan with cyclophosphamide in preparation of HCT). 12374454
Fernandez HF, Tran HT, Albrecht F, Lennon S, Caldera H, Goodman MS. Evaluation of safety and pharmacokinetics of administering intravenous busulfan in a twice-daily or daily schedule to patients with advanced hematologic malignant disease undergoing stem cell transplantation. Biol Blood Marrow Transplant 2002; 8: 486-92. (Among 12 patients receiving intravenous busulfan either as one or two infusions daily for 4 days followed by cyclophosphamide in preparation for HCT, only one developed SOS). 12374453
Bornhauser M, Storer B, Slattery J, Appelbaum FR, Deeg HJ, Hansen J, Martin PJ, et al. Conditioning with fludarabine and targeted busulfan for transplantation of allogeneic hematopoietic stem cells. Blood 2003; 102: 820-6. (Assessment of conditioning regimen of busulfan and fludarabine in preparation for HCT in 42 patients found low rate of toxicity and excellent survival rates). 12676781
De Lima M, Couriel D, Thall PF, Wang X, Madden T, Jones R, Shpall EJ, et al. Once-daily intravenous busulfan and fludarabine: clinical and pharmacokinetic results of a myeloablative, reduced toxicity conditioning regimen for allogeneic stem cell transplantation in AML and MDS. Blood 2004; 104: 857-64. (Assessment of busulfan combined with fludarabine as a conditioning regimen for HCT found low rate of toxicity and improved survival). 15073038
Foschi FG, Savini P, Marano G, Musardo G, Bedeschi E, Girelli F, Emiliani F, et al. Focal nodular hyperplasia after busulfan treatment. Dig Liver Dis 2005; 37: 619-21. (48 year old woman was found to have a 2.9 by 2.5 cm focal nodular hyperplasia after a year of therapy with busulfan for thrombocytosis, which gradually decreased in size upon stopping busulfan and was no longer detectable 2 years later). 15886082
Kusumi E, Kami M, Kanda Y, Murashige N, Seki K, Fujiwara M, Koyama R, et al. Hepatic injury following reduced intensity unrelated cord blood transplantation for adult patients with hematological diseases. Biol Blood Marrow Transplant 2006; 12: 1302-9. (Among 104 patients who underwent reduced intensity cord blood transplantation using melphalan/fludarabine and total body irradiation, liver injury occurred in 36 [35%] which was mainly due to graft-vs-host disease and septicemia; no cases of SOS). 17162212
McDonald GB. Review article: management of hepatic disease following haematopoietic cell transplant. Aliment Pharmacol Ther 2006; 24: 441-52. (Sinusoidal obstruction syndrome arises in first 20-30 days after HCT, case fatality rate is 15-20%, frequency ~38%, but frequency varies by risk factors [cyclophosphamide pharmacokinetics, preexisting liver disease, irradiation dose and use of gemtuzumab], no therapy has proven efficacious but defibrotide and repletion of glutathione deserve evaluation). 16886910
Carreras E, Rosiñol L, Terol MJ, Alegre A, de Arriba F, García-Laraña J, Bello JL, et al.; Spanish Myeloma Group/PETHEMA. Veno-occlusive disease of the liver after high-dose cytoreductive therapy with busulfan and melphalan for autologous blood stem cell transplantation in multiple myeloma patients. Biol Blood Marrow Transplant 2007; 13: 1448-54. (Among 734 patients undergoing autologous HCT for multiple myeloma, SOS occurred in 8% [19 of 240] with 2% mortality [median onset 29 days] receiving busulfan and melphalan, but in only 0.4% [2 of 494: 0.2% mortality, onset 9-13 days] receiving melphalan alone). 18022574
McCune JS, Batchelder A, Deeg HJ, Gooley T, Cole S, Phillips B, Schoch HG, et al. Cyclophosphamide following targeted oral busulfan as conditioning for hematopoietic cell transplantation: pharmacokinetics, liver toxicity, and mortality. Biol Blood Marrow Transplant 2007; 13: 853-62. (Cyclophosphamide pharmacokinetics were determined in 222 patients receiving cyclophosphamide and either busulfan or total body irradiation in preparation of HCT; there was considerable variability in cyclophosphamide levels, being higher in busulfan regimens and higher levels correlating with risk of SOS). 17580264
Gekkurt E, Stoehlmacher J, Stueber C, Wolschke C, Eiermann T, Iacobelli S, Zander AR, et al. Pharmacogenetic analysis of liver toxicity after busulfan/cyclophosphamide-based allogeneic hematopoietic stem cell transplantation. Anticancer Res 2007; 27: 4377-80. (Retrospective analysis of methylene-tetrahydrofolate-reductase [MTHFR] and glutathione S-transferase [GST] polymorphisms among 84 adults receiving busulfan and cyclophosphamide in preparation for HCT found weak association between a MTHFR polymorphism and sinusoidal obstruction syndrome [86% rate in those who were homozygous compared to 39% of those who were heterozygous or wild type]). 18214047
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, antineoplastic agents were rarely implicated; 3 were considered due to mercaptopurine and 1 each due to bortezombin, cyclophosphamide, docetaxel, and temozolomide). 18955056
Ulrickson M, Aldridge J, Kim HT, Hochberg EP, Hammerman P, Dube C, Attar E, Ballen KK, Dey BR, McAfee SL, Spitzer TR, Chen YB. Busulfan and cyclophosphamide (Bu/Cy) as a preparative regimen for autologous stem cell transplantation in patients with non-Hodgkin lymphoma: a single-institution experience. Biol Blood Marrow Transplant 2009; 15: 1447-54. (Among 78 patients with non-Hodgkin lymphoma undergoing autologous HCT after conditioning with busulfan and cyclosphosphamide, 3 [4%] developed SOS, none fatal). 19822305
McDonald GB. Hepatobiliary complications of hematopoietic cell transplantation, 40 years on. Hepatology 2010; 51: 1450-60. (Review of liver complications of HCT, which have become less frequent with better understanding of their cause and means of prevention; the rate of SOS has decreased because of avoidance of more aggressive ablative therapies [total body irradiation and high dose cyclophosphamide], better understanding of pharmacokinetics of the alkylating agents, and lower frequency of hepatitis C in HCT recipients). 20373370
O'Donnell PH, Artz AS, Undevia SD, Pai RK, Del Cerro P, Horowitz S, Godley LA, et al. Phase I study of dose-escalated busulfan with fludarabine and alemtuzumab as conditioning for allogeneic hematopoietic stem cell transplant: reduced clearance at high doses and occurrence of late sinusoidal obstruction syndrome/veno-occlusive disease. Leuk Lymphoma 2010; 51: 2240-9. (Safety study of busulfan based therapy for HCT recipients; the risk of SOS appeared to correlate with high exposures to busulfan). 20919852
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but few anticancer drugs were implicated [1 case each for melphalan and gemtuzumab]). 20949552
Cantoni N, Gerull S, Heim D, Halter J, Bucher C, Buser A, Tsakiris DA, et al. Order of application and liver toxicity in patients given BU and CY containing conditioning regimens for allogeneic hematopoietic SCT. Bone Marrow Transplant 2011; 46: 344-9. (Retrospective analysis of liver toxicity after conditioning regimens of busulfan followed by cyclosphospamde versus the reverse order found higher rate of SOS when busulfan was given first [12.5%: 2 of 16 patients] than when it was given after cyclosphosphamide [0 of 59 patients]). 20548339
Pai RK, van Besien K, Hart J, Artz AS, O'Donnell PH. Clinicopathologic features of late-onset veno-occlusive disease/sinusoidal obstruction syndrome after high dose intravenous busulfan and hematopoietic cell transplant. Leuk Lymphoma 2012; 53: 1552-7. (Among 36 patients with advanced malignancies undergoing HCT after high escalating doses of busulfan with fludarabine and alemtuzumab, 8 developed late onset SOS, arising 33 to 77 days after HCT with ascites, hepatomegaly and jaundice [bilirubin 1.3-22.9 mg/dL]; four died). 22280517
Perkins JB, Kim J, Anasetti C, Fernandez HF, Perez LE, Ayala E, Kharfan-Dabaja MA, et al. Maximally tolerated busulfan systemic exposure in combination with fludarabine as conditioning before allogeneic hematopoietic cell transplantation. Biol Blood Marrow Transplant 2012; 18: 1099-107. (Among 72 patients with malignancies undergoing HCT after a conditioning regimen of fludarabine with different levels of systemic exposures to busulfan, SOS occurred in 0 of 40 given the standard exposure, but 2 of 29 with the intermediate high level and 3 of 3 at the highest level; ALT elevations [>3 times ULN] occurring in 20%, 31% and 100% of subjects).22198540
Dignan FL, Wynn RF, Hadzic N, Karani J, Quaglia A, Pagliuca A, Veys P, et al.; Haemato-oncology Task Force of British Committee for Standards in Haematology; British Society for Blood and Marrow Transplantation. BCSH/BSBMT guideline: diagnosis and management of veno-occlusive disease (sinusoidal obstruction syndrome) following haematopoietic stem cell transplantation. Br J Haematol 2013; 163: 444-57. (Guidelines for diagnosis, prophylaxis and treatment of SOS after HCT from a British task force recommends using clinical criteria for diagnosis and defibrotide for prophylaxis and treatment combined with judicious clinical care, and mentions that busulfan particularly in combination with cyclophosphamide is a risk factor). 24102514
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5%] were attributed to antineoplastic agents, but none were due to busulfan). 25754159
Chen S, Osborn JD, Chen X, Boyer MW, McDonald GB, Hildebrandt GC. Subacute hepatic necrosis mimicking veno-occlusive disease in a patient with HFE H63D homozygosity after allogeneic hematopoietic cell transplantation with busulfan conditioning. Int J Hematol 2015; 102: 729-31. (31 year old man with myelogenous leukemia who underwent allogenic hematopoietic cell transplantation after myeloablation with busulfan and fludarabine developed fever, rash, abdominal pain and jaundice with ascites [bilirubin 1.3 rising to 5.3 mg/dL, ALT 330 to 1339 U/L, and Alk P 84 U/L], biopsy being interpreted as showing hepatitis rather than sinusoidal obstruction or graft-vs-host disease). 26497867

## OTHER REFERENCE LINKS

1. Recent References on Busulfan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Busulfan/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Busulfan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Busulfan)